# Bromelain

## OVERVIEW

### Introduction

Bromelain is a concentrated mixture of proteins and enzymes made from the stems and fruit of the pineapple plant (Ananas comosus) that has antiinflammatory and digestive properties, and is used topically to treat wounds and burns and orally for digestive problems and sinusitis. Bromelain is generally recognized as safe (GRAS) and has not been linked to serum aminotransferase elevations nor to instances of clinically apparent liver injury.

### Background

Bromelain is a concentrated mixture of proteolytic enzymes made from the stems and fruit of the pineapple plant (Ananas comosus) that has antiinflammatory and digestive properties, and is used topically to treat wounds and burns or orally for digestive complaints and sinusitis. Bromelain is typically concentrated, but only partially purified because its proteolytic enzymes can be inactivated by purification techniques. The major compounds in bromelain are enzymes such as is endopeptidases, phosphatases, glucosidases, peroxidases and cellulases and various glycoproteins. Applied topically, the proteolytic enzymes may help in wound debridement and burn management. In cooking, bromelain is used as a meat tenderizer. Orally, the enzymes and proteins of bromelain are absorbed intact to some degree and may possibly be helpful for digestive complains, infections and even metabolic problems. Bromelain has been used to treat symptoms of indigestion, nausea and abdominal pain as well as medical conditions including sinusitis, osteoarthritis, rheumatoid arthritis, prostatitis, inflammatory bowel disease, and multiple sclerosis. However, bromelain has not been proven to be of convincing benefit for any condition and is not formally approved for use for any medical disease in the United States. Nevertheless, it is used orally in dietary supplements and topically to help in wound healing and debridement of dead tissue. Bromelain is approved in Europe for topical use in wound and burn management. Bromelain is available in many commercial herbal preparations alone and as a part of multiingredient dietary supplements. The dose varies by source and medical use between 200 and 2000 mg daily. Bromelain is generally recognized as safe (GRAS, according to the FDA definition), and side effects are uncommon and typically are mild degrees of abdominal discomfort and nausea. Hypersensitivity reactions including urticaria and rash have been reported but are usually mild and resolve rapidly with discontinuation. Rare instances of anaphylaxis have been described with its use.

### Hepatotoxicity

Oral bromelain has been evaluated in more than 100 clinical trials for conditions such as sinusitis, osteoarthritis, and rheumatoid arthritis, and is usually described as well tolerated and without significant side effects or adverse events. These studies have rarely reported results of liver enzyme testing, and most studies were for short term use only (3 to 6 days) and included a limited number of subjects. Nevertheless, despite widespread use, there have been no reports of liver injury, jaundice or hepatotoxicity associated with oral or topical use of bromelain. In large case series, systematic reviews, and reports from pharmacovigilance registries on liver injury due to botanical products, bromelain has not been mentioned or listed.

Likelihood score: E (unlikely cause of clinically apparent liver injury).

Other Names: Bromelins, Ananas comosus, Pineapple extract

Drug Class: Herbal and Dietary Supplements

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Bromelain – Generic

DRUG CLASS

Herbal and Dietary Supplements

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Bromelain | 9001-00-7 | C39-H66-N2-O29 | Not Available

## ANNOTATED BIBLIOGRAPHY

References updated: 10 February 2024

Abbreviations: DSHEA, Dietary Supplement Health and Education Act; HDS, herbal and dietary supplements.

Zimmerman HJ. Unconventional drugs. Miscellaneous drugs and diagnostic chemicals. In, Zimmerman, HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott,1999: pp. 731-4. (Expert review of hepatotoxicity published in 1999; several herbal medications linked to liver injury are discussed, but bromelain is not mentioned).
Seeff L, Stickel F, Navarro VJ. Hepatotoxicity of herbals and dietary supplements. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 631-58. (Review of hepatotoxicity of herbals does not mention bromelain).
Bromelain. PDR for Herbal Medicines. 4th ed. Montvale, New Jersey: Thomson Healthcare Inc. 2007; pp 945-8. (Compilation of short monographs on herbal medications and dietary supplements).
Taub SJ. The use of bromelains in sinusitis: a double-blind clinical evaluation. Eye Ear Nose Throat Mon. 1967;46:361-2. (Among 59 adults with acute or chronic sinusitis treated with bromelain or placebo four times daily for 6 days concurrently with antibiotics and decongestants, an excellent response was reported in 69% on bromelain vs 23% on placebo, and although there were no differences in improvements in headache and pain, there were also no “toxic manifestations”). 5342723
Seltzer AP. Adjunctive use of bromelains in sinusitis: a controlled study. Eye Ear Nose Throat Mon. 1967;46:1281-8. (Among 49 patients with symptoms of sinusitis treated for 6 days, good to excellent responses occurred in 80% of patients on bromelain treatment vs 50% on placebo, although rates of improvements in headache and pain were not different in the two groups; “side effects were not encountered”). 4864820
Akhtar NM, Naseer R, Farooqi AZ, Aziz W, Nazir M. Oral enzyme combination versus diclofenac in the treatment of osteoarthritis of the knee--a double-blind prospective randomized study. Clin Rheumatol. 2004;23:410-5. (Among 103 patients with painful osteoarthritis of the knee treated with bromelain or diclofenac orally for 6 weeks, improvements in symptom scores were similar in the two groups as were adverse event rates [28% vs 23%] and while median values of ALT, AST and GGT decreased with bromelain, they increased with diclofenac; rates of abnormal values were not reported). 15278753
Kerkhoffs GM, Struijs PA, de Wit C, Rahlfs VW, Zwipp H, van Dijk CN. A double blind, randomised, parallel group study on the efficacy and safety of treating acute lateral ankle sprain with oral hydrolytic enzymes. Br J Sports Med. 2004;38:431-5. (Among 674 patients with acute unilateral ankle sprain treated with 7 different combinations of hydrolytic enzymes [bromelain, rutoside, and trypsin] or placebo 3 times daily for 10 days, decreases in pain, ankle volume, and range of motion were similar in the 8 different groups while adverse events were more frequent with enzyme therapy, although there was only one serious adverse event [thrombosis in the calf judged to be unrelated to the therapy]; no mention of ALT elevations or hepatotoxicity). 15273178
Russo MW, Galanko JA, Shrestha R, Fried MW, Watkins P. Liver transplantation for acute liver failure from drug-induced liver injury in the United States. Liver Transpl 2004; 10: 1018-23. (Among ~50,000 liver transplants reported to UNOS between 1990 and 2002, 270 [0.5%] were done for drug induced acute liver failure, including 7 [5%] for herbal medications, none were specifically attributed to a product containing bromelain). 15390328
Braun JM, Schneider B, Beuth HJ. Therapeutic use, efficiency and safety of the proteolytic pineapple enzyme Bromelain-POS in children with acute sinusitis in Germany. In Vivo. 2005;19:417-21. (Among 116 children with sinusitis treated with bromelain, standard therapy alone, or the combination of the two, duration of symptoms was 6.7 vs 8.0 days vs 9.1 days, while side effects were rare, although one child with pineapple allergies developed a mild, self-limiting allergic reaction; no mention of ALT elevations or hepatotoxicity). 15796206
Guo R, Canter PH, Ernst E. Herbal medicines for the treatment of rhinosinusitis: a systematic review. Otolaryngol Head Neck Surg. 2006;135:496-506. (A systematic review of the literature on use of herbal products in sinusitis identified 10 randomized controlled trials, 3 of which evaluated bromelain, all reported positive findings without any serious adverse events and either no or only mild side effects with similar rates compared to placebo controls). 17011407
García-Cortés M, Borraz Y, Lucena MI, Peláez G, Salmerón J, Diago M, Martínez-Sierra MC, et al. [Liver injury induced by "natural remedies": an analysis of cases submitted to the Spanish Liver Toxicity Registry]. Rev Esp Enferm Dig 2008; 100: 688-95. Spanish. (Among 521 cases of drug induced liver injury submitted to Spanish registry, 13 [2%] were due to herbals, but none were attributed to bromelain). 19159172
Navarro VJ. Herbal and dietary supplement hepatotoxicity. Semin Liver Dis 2009; 29: 373-82. (Review of the problems of causality assessment in herbal and dietary supplement [HDS] associated liver disease, including the variable clinical presentations, the complexity and lack of information on their components, absence of controlled trials demonstrating safety and efficacy, the possibility of contamination or incorrect labeling, and the frequent underreporting of herbal use by patients. Regulation of HDS is under DSHEA, which requires manufacturers to determine safety and prohibits claims of efficacy in treating specific diseases. The US Pharmacopeia sets standards for food and drugs and includes HDS; HDS induced liver injury is a growing problem and currently accounts for at least 10% of cases of acute liver injury due to medications). 19826971
Jacobsson I, Jönsson AK, Gerdén B, Hägg S. Spontaneously reported adverse reactions in association with complementary and alternative medicine substances in Sweden. Pharmacoepidemiol Drug Saf 2009; 18: 1039-47. (Review of 778 spontaneous reports of adverse reactions to herbal products to a Swedish Registry does not list or mention bromelain). 19650152
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 [11%] were attributed to drug induced liver injury of which 12 [9%] were due to herbals, but none were attributed to bromelain). 20949552
Bromelain. Monograph. Altern Med Rev. 2010;15:361-8. (Summary of purported biologic effects and clinical uses of bromelain in multiple conditions including antibiotic potentiation, diarrhea and intestinal infections, cardiovascular diseases, inflammatory bowel disease, multiple sclerosis, musculoskeletal injuries, osteoarthritis, prostatitis, renal disease, respiratory conditions, rheumatoid arthritis, and wound debridement, discusses side effects but does not mention ALT elevations or hepatotoxicity). 21194252
Teschke R, Wolff A, Frenzel C, Schulze J, Eickhoff A. Herbal hepatotoxicity: a tabular compilation of reported cases. Liver Int 2012; 32: 1543-56. (A systematic compilation of all publications on the hepatotoxicity of specific herbals identified 185 publications on 60 different herbs, herbal drugs and supplements, but bromelain was not listed or mentioned). 22928722
Navarro VJ, Barnhart H, Bonkovsky HL, Davern T, Fontana RJ, Grant L, Reddy KR, et al. Liver injury from herbals and dietary supplements in the U.S. Drug-Induced Liver Injury Network. Hepatology 2014; 60: 1399-408. (Among 85 cases of HDS associated liver injury [not due to anabolic steroids] enrolled in a US prospective study between 2004 and 2013, none were attributed to a product containing bromelain). 25043597
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a prospective database between 2004 and 2012, HDS were implicated in 145 [16%], the single major herbal cause being green tea and none were attributed to bromelain [see also Navarro et al Hepatology 2014]). 25754159
García-Cortés M, Robles-Díaz M, Ortega-Alonso A, Medina-Caliz I, Andrade RJ. Hepatotoxicity by dietary supplements: A tabular listing and clinical characteristics. Int J Mol Sci 2016; 17: 537. (Listing of published cases of liver injury from HDS products, but does not mention or list bromelain). 27070596
Brown AC. An overview of herb and dietary supplement efficacy, safety and government regulations in the United States with suggested improvements. Part 1 of 5 series. Food Chem Toxicol 2017; 107: 449-71. (Summary of the US regulations on safety and efficacy of herbal and dietary supplements). 27818322
Brown AC. Liver toxicity related to herbs and dietary supplements: Online table of case reports. Part 2 of 5 series. Food Chem Toxicol 2017; 107: 472-501. (Description of an online compendium of cases of liver toxicity attributed to HDS products, does not mention or list bromelain). 27402097
Navarro VJ, Khan I, Björnsson E, Seeff LB, Serrano J, Hoofnagle JH. Liver injury from herbal and dietary supplements. Hepatology 2017; 65: 363-73. (Review of the problems of liver injury and HDS products, mentions that multiingredient dietary supplements account for the major of cases, but does not mention a product with bromelain as a component). 27677775
Ballotin VR, Bigarella LG, Brandão ABM, Balbinot RA, Balbinot SS, Soldera J. Herb-induced liver injury: Systematic review and meta-analysis. World J Clin Cases. 2021;9:5490-5513. (Systematic review of the literature on herb induced liver injury identified 446 references describing 936 cases due to 79 different herbal products, the most common being He Shou Wu [91], green tea [90] Herbalife products [64], kava kava [62] and greater celandine [48]; bromelain was not among the 79 implicated products). 34307603
Bessone F, García-Cortés M, Medina-Caliz I, Hernandez N, Parana R, Mendizabal M, Schinoni MI, et al. Herbal and dietary supplements-induced liver injury in Latin America: experience from the LATINDILI Network. Clin Gastroenterol Hepatol. 2022;20:e548-e563. (Among 367 cases of hepatotoxicity enrolled in the Latin American DILI Network between 2011 and 2019, 29 [8%] were attributed to herbal products, the most frequent being green tea [n=7], Herbalife products [n=5] and garcinia [n=3], while bromelain is not mentioned). 33434654
Kumar V, Mangla B, Javed S, Ahsan W, Kumar P, Garg V, Dureja H. Bromelain: a review of its mechanisms, pharmacological effects and potential applications. Food Funct. 2023;14:8101-8128. (Extensive review of the source, chemical components, method of preparation, pharmacologic activities, mechanism of action, safety, and clinical efficacy of bromelain mentions side effects of allergic reactions including anaphylaxis, digestive complains of nausea, vomiting, diarrhea and abdominal discomfort, potential anticoagulant activity, but concludes that it is generally safety in usual doses and allergic reactions are rare; no mention of hepatotoxicity or ALT elevations). 37650738
Shoham Y, Gasteratos K, Singer AJ, Krieger Y, Silberstein E, Goverman J. Bromelain-based enzymatic burn debridement: A systematic review of clinical studies on patient safety, efficacy and long-term outcomes. Int Wound J. 2023;20:4364-4383. (Systematic review of the literature on the use of bromelain for enzymatic burn debridement identified 34 clinical studies and concluded that bromelain has positive effects on functional and cosmetic outcomes of major burns, and that there is no strong evidence of adverse events such as infections or hemorrhage). 37455553

## OTHER REFERENCE LINKS

Recent References on Bromelain: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=Bromelain+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))

Trials on Bromelain: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Bromelain)